# Diethylpropion

## OVERVIEW

### Introduction

Diethylpropion is a sympathomimetic amine and anorectic agent used for the short-term therapy of obesity. Diethylpropion has not been linked to either serum enzyme elevations or to clinically apparent acute liver injury.

### Background

Diethylpropion (dye eth" il proe' pee on) is a structural analogue to amphetamine and has similar activity in suppressing appetite, but has few of the other central nervous system effects of amphetamines and less abuse potential. Diethylpropion was approved as a therapy for obesity in the United States in 1959 and is recommended only for short term use (less than 12 weeks). Diethylpropion is available by prescription as 25 mg immediate release and 75 mg controlled release tablets in generic forms and formerly under the trade name Tenuate. The usual dose is 75 mg daily either as 25 mg (immediate release) 1 hour before meals or 75 mg (controlled release) once daily. Diethylpropion is a Schedule IV controlled substance, meaning that it has a proven but low potential for abuse and has an accepted medical use. Common side effects include nervousness, excitability, insomnia, headache, dry mouth, sweating, nausea, constipation, and thirst. Rare severe adverse events include atrial fibrillation, acute psychosis and pulmonary hypertension.

### Hepatotoxicity

Diethylpropion has not been linked to an increased rate of serum enzyme elevations during therapy; however, actual results of ALT monitoring during diethylpropion therapy have rarely been reported. Despite long term availability and wide use of diethylpropion, there have been no published reports linking it to clinically apparent acute liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The safety of diethylpropion is perhaps due to its rapid urinary excretion. Nevertheless, it is extensively metabolized in the liver and some of the metabolites are biologically active.

Drug Class: Weight Loss Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diethylpropion – Generic, Tenuate®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=diethylpropionverapamil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Diethylpropion | 90-84-6 | C13-H19-N-O | Diethylpropion Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity published in 1999; diethylpropion is not discussed).
Westfall TC, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 277-334. (Textbook of pharmacology and therapeutics; diethylpropion is discussed as a sympathomimetic agent used for weight loss).
Carney DE, Tweddell ED. Double blind evaluation of long acting diethylpropion hydrochloride in obese patients from a general practice. Med J Aust 1975; 1: 13-5. (102 obese patients enrolled in controlled trial of diethylpropion vs placebo for 16 weeks with subsequent cross-over; there were no serious adverse events and side effects were mild and transient; no mention of ALT elevations or hepatotoxicity). 1092973
Altschuler S, Conte A, Sebok M, Marlin RL, Winick C. Three controlled trials of weight loss with phenylpropanolamine. Int J Obes 1982; 6: 549-56. (Controlled trial of phenylpropanolamine-caffeine vs placebo vs mazindol vs diethylpropion in 201 obese patients; adverse reactions included dry mouth, diarrhea, constipation and diuresis; no serious adverse events and no mention of ALT elevations or hepatotoxicity). 6761288
Parsons WB Jr. Controlled-release diethylpropion hydrochloride used in a program for weight reduction. Clin Ther 1981; 3: 329-35. (49 obese patients were treated with placebo vs diethylpropion for 12 weeks; side effects included headaches, dry mouth, nervousness and nausea; no serious adverse events or liver injury occurred; ALT monitoring was not done). 7471128
Bray GA. A concise review on the therapeutics of obesity. Nutrition 2000 16: 953-60. (Review of drug treatment of obesity; hepatotoxicity is not discussed). 11054601
Haddock CK, Poston WS, Dill PL, Foreyt JP, Ericsson M. Pharmacotherapy for obesity: a quantitative analysis of four decades of published randomized clinical trials. Int J Obes Relat Metab Disord 2002; 26: 262-73. (Metaanalysis of published studies of antiobesity medications; diethylpropion was evaluated in 13 studies published between 1965-83; no discussion of side effects). 11850760
Colman E. Anorectics on trial: a half century of federal regulation of prescription appetite suppressants. Ann Intern Med 2005; 143: 380-5. (History of the approval of medications for obesity from initial agents approved in 1947 to sibutramine in 1997; diethylpropion was first approved in 1959, before the Kefauver-Harris amendment requiring proof of efficacy from controlled trials). 6144896
Li Z, Maglione M, Tu W, Mojica W, Arterburn D, Shugarman LR, Hilton L, et al. Meta-analysis: pharmacologic treatment of obesity. Ann Intern Med 2005; 142: 532-46. (Systematic review of efficacy and safety of medications for obesity; diethylpropion was evaluated in 9 placebo controlled trials of therapy for 6 to 52 weeks and was associated with modest additional weight loss; no data on adverse events were reported but evidently there were no serious adverse events attributed to therapy). 15809465
Bray GA. Drug Insight: appetite suppressants. Nat Clin Pract Gastroenterol Hepatol 2005; 2: 89-95. (Review of the mechanism of action and clinical efficacy of drugs that suppress appetite including sympathomimetic agents [amphenatmine, phentermine, sibutramine], serotonin reuptake inhibitors [bupropion, fenfluramine, fluoxetine], GABAergic agents [topiramate, zonisamide], cannabinoid antagonists [rimonabant] and various peptides [leptin, neuropeptide Y, melanocortin-4]). 16265126
Ioannides-Demos LL, Proietto J, Tonkin AM, McNeil JJ. Safety of drug therapies used for weight loss and treatment of obesity. Drug Saf 2006; 29: 277-302. (Review of safety of drug therapy of obesity; the only mention of liver adverse events was “a case of reversible hepatotoxicity associated with sibutramine”). 16569079
Cercato C, Roizenblatt VA, Leança CC, Segal A, Lopes Filho AP, Mancini MC,Halpern A. A randomized double-blind placebo-controlled study of the long-term efficacy and safety of diethylpropion in the treatment of obese subjects. Int J Obes (Lond) 2009;33: 857-65. (Randomized controlled trial of diethylpropion vs placebo for 24 weeks and open label use thereafter; common side effects were dry mouth, insomnia, constipation, headache and dizziness; no serious adverse events or hepatotoxicity). 19564877
Kang JG, Park CY. Anti-obesity drugs: a review about their effects and safety. Diabetes Metab J 2012; 36: 13-25. (Review of the safety and efficacy of current and potentially future medications for obesity; mentions that no serious adverse events have been reported in controlled trials of diethylpropion). 2363917
Cheung BM, Cheung TT, Samaranayake NR. Safety of antiobesity drugs. Ther Adv Drug Saf 2013; 4: 171-81. (Systematic review of the literature on the efficacy and safety of drugs for weight loss; diethylpropion is described as effective in short term weight loss and generally with mild-to-moderate adverse events which are largely cardiovascular; no mention of hepatotoxicity or ALT elevations). 25114779
Suplicy H, Boguszewski CL, Dos Santos CM, do Desterro de Figueiredo M, Cunha DR, Radominski R. A comparative study of five centrally acting drugs on the pharmacological treatment of obesity. Int J Obes (Lond) 2014; 38: 1097-103. (Among 174 obese women treated with diethylpropion, fenproporex, mazindol, fluoxetine or sibutramine for 52 weeks, weight loss was greater with diethylpropion than placebo, but dry mouth, constipation, insomnia, anxiety and irritability were more common; no serious adverse events occurred; ALT levels not mentioned). 24287940
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none of them were attributed to drugs for weight loss). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to diethylpropion). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Diethylpropion: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Diethylpropion+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Diethylpropion: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=diethylpropion)